# Vesicular Monoamine Transporter 2 (VMAT2) Inhibitors

## OVERVIEW

### Introduction

The vesicular monoamine transporter type 2 (VMAT2) inhibitors are agents that cause a depletion of neuroactive peptides such as dopamine in nerve terminals and are used to treat chorea due to neurodegenerative diseases (such as Huntington chorea) or dyskinesias due to neuroleptic medications (tardive dyskinesia). As of 2019, three VMAT2 inhibitors have become available in the United States for management of dyskinesia syndromes, each with a somewhat different spectrum of approved indications: tetrabenazine (Xenazine and generics: 2008), deutetrabenazine (Austedo: 2017) and valbenazine (Ingressa: 2017). The VMAT2 inihibitors have not been associated with serum enzyme elevations during therapy or linked to instances of clinically apparent liver injury, but they have had limited general clinical use.

### Tetrabenazine

#### Background

Tetrabenazine (tet" ra ben' a zeen) is an inhibitor of synaptic vesicular monoamine transporter 2 (VMAT2), the inhibition of which causes a depletion of neuroactive monoamines (serotonin, norepinephrine and particularly dopamine) in nerve terminals. The reduction in these active neurotransmitters results in a decrease in spontaneous jerk-like movements of the extremities, trunk, face and neck (chorea) that are typical of patients with degenerative neurologic conditions such as Huntington disease. Tetrabenazine, however, does not prevent the progression or alter the outcome of these diseases. Tetrabenazine was approved by the FDA in 2008 as an orphan disease agent for treatment of the chorea associated with Huntington disease. While it is used off-label to treat other abnormal movement disorders, tetrabenazine is not formally approved for those indications. Tetrabenazine is available as tablets of 12.5 and 25 mg generically and under the brand name Xenazine. The recommended initial dose is 12.5 mg once daily, with subsequent careful increase to a maximum of 50 mg given in three divided doses daily. Because of the variable metabolism of tetrabenazine (by CYP 2D6), the maintenance dose varies by individual, and inducers or inhibitors of CYP 2D6 should be avoided. Poor CYP 2D6 metabolizers may require even higher doses. Common side effects include fatigue, sedation, somnolence, insomnia, depression, restlessness (akathisia), agitation, and nausea. Rare potentially serious adverse events include severe depression, suicidality, symptomatic hypotension, prolongation of the QTc interval and neuroleptic malignant syndrome.

#### Hepatotoxicity

Tetrabenazine has not been associated with rates of serum enzyme elevations greater than occur with placebo therapy, but information on liver test results during therapy is limited and occasional instances of asymptomatic ALT elevations leading to drug discontinuation or dose modification have been reported by the sponsor. In prelicensure pivotal registration trials in several hundred patients, tetrabenazine was not associated with cases of jaundice or hepatitis. Since licensure, there have been no published reports of clinically apparent liver injury, jaundice or hepatitis attributed to tetrabenazine. Thus, clinically apparent liver injury with jaundice due to tetrabenazine must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

#### Mechanism of Injury

The mechanism by which tetrabenazine might cause liver injury is not known. Tetrabenazine undergoes hepatic metabolism largely by CYP 2D6 and is susceptible to drug-drug interactions with agents that induce or inhibit this enzyme.

### Deutetrabenazine

#### Background

Deutetrabenazine (doo" tet ra ben' a zeen) is an inhibitor of synaptic vesicular monoamine transporter 2 (VMAT2), the inhibition of which causes a depletion of neuroactive monoamines (serotonin, norepinephrine and particularly dopamine) in nerve terminals. The reduction in these active neurotransmitters results in a decrease in spontaneous jerk-like movements of the extremities, trunk, face and neck (dyskinesia, chorea) that are typical of patients with degenerative neurologic conditions such as Huntington disease and the syndrome known as tardive dyskinesia. Tardive dyskinesia is a late ("tardive") and sometimes persistent complication of therapy with dopamine receptor anagonists including antipsychotic, antidepressant and antiemetic medications. The movements can involve any part of the body, but most characteristically cause facial tics and tongue rolling which can be particularly distressing and interfere with speech and eating. Deutetrabenazine was found to ameliorate the involuntary movements of tardive dyskinesia and Huntington disease but does not appear to prevent or retard their progression. Deutetrabenazine was approved by the FDA in 2017 for treatment of the movement disorders associated with tardive dyskinesia and Huntington disease. It is available as tablets of 6, 9 and 12 mg under the brand name Austedo. Deutetrabenazine is similar in chemical structure to tetrabenazine but has several molecules of deuterium instead of hydrogen, which creates a stronger bond with carbon and higher molecular weight. These features make it less suceptible to CYP 2D6 metabolism, improving its pharmacologic properties and allowing for twice daily dosing with more reliable drug exposure. The recommended initial dose is 6 mg once daily, with subsequent careful increase to a maximum of 48 mg (24 mg twice daily). Because of the hepatic metabolism of deutetrabenazine, the maintenance dose may be less in patients taking potent CYP 2D6 inhibitors. Common side effects resemble those of tetrabenazine and include fatigue, sedation, somnolence, insomnia, depression, restlessness (akathisia), agitation, and nausea. Rare potentially serious adverse events reported with tetrabenazine include severe depression, suicidality, symptomatic hypotension, prolongation of the QTc interval and neuroleptic malignant syndrome.

#### Hepatotoxicity

Deutetrabenazine has not been associated with rates of serum enzyme elevations greater than occur with placebo therapy, but information on liver test results during therapy is limited. In prelicensure pivotal registration trials in several hundred patients, deutetrabenazine was not associated with cases of jaundice or hepatitis. Since licensure, there have been no published reports of clinically apparent liver injury, jaundice or hepatitis attributed to deutetrabenazine. Thus, clinically apparent liver injury with jaundice due to deutetrabenazine must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

#### Mechanism of Injury

The mechanism by which deutetrabenazine might cause liver injury is not known. Deutetrabenazine undergoes hepatic metabolism largely by CYP 2D6 and is susceptible to drug-drug interactions with agents that are strong inhibitors of enzyme.

### Valbenazine

#### Background

Valbenazine (val ben' a zeen) is an inhibitor of synaptic vesicular monoamine transporter 2 (VMAT2), the inhibition of which causes a depletion of neuroactive monoamines (serotonin, norepinephrine and particularly dopamine) in nerve terminals. The reduction in these active neurotransmitters results in a decrease in spontaneous jerk-like movements of the extremities, trunk, face and neck (chorea) that are typical of patients with degenerative neurologic conditions such as Huntington disease and the abnormal involuntary movements of the condition known as tardive dyskinesia. Tardive dyskinesia is a late ("tardive") and sometimes persistent complication of therapy with dopamine receptor anagonists including antipsychotic, antidepressant and antiemetic medications. The movements can involve any part of the body, but most characteristically cause facial tics and tongue rolling which can be particularly distressing and interfere with speech and eating. Valbenazine has been shown to decrease the frequency of involuntary movements in patients with tardive dyskinesia and was approved for this use in 2017. Unlike deutetrabenazine, valbenazine has not been approved for use in Huntington disease. Valbenazine is available as tablets of 40 mg under the brand name Ingrezza. The recommended initial dose is 40 mg once daily, with subsequent increase to a maximum of 80 mg daily. Valbenazine is a prodrug that is metabolized by CYP 3A4 in the liver to its active metabolite (alpha-dihydrotetrabenazine) which is subsequently metabolized by CYP 2D6. For these reasons, its use with strong inhibitors of CYP 3A4 or 2D6 should be avoided or the dose reduced accordingly. Common side effects are similar to those of tetrabenazine and include fatigue, sedation, somnolence, insomnia, depression, restlessness (akathisia), agitation, and nausea. Rare potentially serious adverse events include severe depression, suicidality, symptomatic hypotension, prolongation of the QTc interval and neuroleptic malignant syndrome.

#### Hepatotoxicity

In prelicensure studies, valbenazine was not been associated with rates of serum enzyme elevations greater than occurred with placebo therapy, and no instances of clinically apparent liver injury, jaundice or hepatitis was reported, although a case of "reactivation of viral hepatitis" was reported in a patient with preexisting hepatitis C virus infection. Valbenazine has had limited general clinical use, but there have been no published reports of clinically apparent liver injury with jaundice associated with its use. Thus, clinically apparent liver injury due to valbenazine must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

#### Mechanism of Injury

The mechanism by which valbenazine might cause liver injury is not known. Valbenazine undergoes hepatic metabolism by CYP 3A4 followed by CYP 2D6 and is susceptible to drug-drug interactions with agents that induce or inhibit these enzymes.

Drug Class: Genetic Disorder Agents, Huntington Disease Agents (for Chorea)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Deutetrabenazine – Austedo®

Tetrabenazine – Generic, Xenazine®

Valbenazine – Ingrezza®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tetrabenazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Deutetrabenazine | 1392826-25-3 | C19-H21-D6-N-O3 (USP) C19-H27-N-O3 (FDA) | 2D chemical structure of 1392826-25-3
Tetrabenazine | 58-46-8 | C19-H27-N-O3 | Tetrabenazine Chemical Structure
Valbenazine | 1025504-45-3 | C24-H38-N2-O4 | 2D chemical structure of 1025504-45-3

## ANNOTATED BIBLIOGRAPHY

References updated: 02 April 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 does not discuss tetrabenazine).
Free RB, Clark J, Amara S, Sibley DR. Neurotransmission and the central nervous system. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 243-65. (Textbook of pharmacology and therapeutics).
Roberson ED. Huntington's disease. Treatment of central nervous system degenerative diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 327-38. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Huntington Study Group. Tetrabenazine as antichorea therapy in Huntington disease: a randomized controlled trial. Neurology 2006; 66: 366-72. (Among 84 patients with Huntington disease and chorea treated with tetrabenazine or placebo for 12 weeks, chorea scores were less with tetrabenazine, but adverse events included restlessness, agitation, depression and suicidality; 3 patients developed ALT elevations, but without symptoms or jaundice and 2 resolved without and one with dose adjustment). 16476934
Frank S. Tetrabenazine as anti-chorea therapy in Huntington disease: an open-label continuation study. Huntington Study Group/TETRA-HD Investigators. BMC Neurol 2009; 9: 62. (Among 75 patients with Huntington disease who completed a 12 week controlled trial and were continued on tetrabenazine for up to 2 years, side effects included sedation, depression, anxiety, insomnia and akathisia; 3 patients had ALT elevations, but all resolved or improved despite continued therapy). 20021666
Tetrabenazine (Xenazine) for Huntington's chorea. Med Lett Drugs Ther 2009; 51 (1304): 7-8. (Concise summary of the mechanism of action, clinical efficacy, side effects and costs of tetrabenazine, a drug available for several decades that had been recently approved for use in the US, mentions side effects of depression and suicidality, but does not mention ALT elevations or hepatotoxicity). 19172140
Frank S. Tetrabenazine: the first approved drug for the treatment of chorea in US patients with Huntington disease. Neuropsychiatr Dis Treat 2010; 6 :657-65. (Summary of the clinical features and course of Huntington disease and its management including use of the recently approved tetrabenazine; no discussion of hepatic adverse events). 20957126
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to tetrabenazine). 20949552
Leung JG, Breden EL. Tetrabenazine for the treatment of tardive dyskinesia. Ann Pharmacother 2011; 45: 525-31. (Systematic review of the literature on use of tetrabenazine for the chorea of tardive dyskinesia; mentions side effects of drowsiness, Parkinsonism and depression, but does not mention ALT elevations or hepatotoxicity). 21487088
Chen JJ, Ondo WG, Dashtipour K, Swope DM. Tetrabenazine for the treatment of hyperkinetic movement disorders: a review of the literature. Clin Ther 2012; 34: 1487-504. (Review of the mechanism of action, clinical efficacy and safety of tetrabenazine for treatment of hyperkinetic disorders; mentions that it is "well tolerated, although fatalities and severe reactions have been reported"; no mention of ALT elevations or hepatotoxicity). 22749259
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to tetrabenazine). 23419359
Shen V, Clarence-Smith K, Hunter C, Jankovic J. Safety and Efficacy of Tetrabenazine and Use of concomitant medications during long-term, open-label treatment of chorea associated with Huntington's and other diseases. Tremor Other Hyperkinet Mov (N Y) 2013; 3. (Among 98 patients with Huntington disease and 47 with other conditions and chorea who were treated with tetrabenazine [12.5 to 300 mg daily] for up to 11 years, 75% had a very good response at the optimal dose, and side effects included somnolence [45%], insomnia [28%], depression [27%], weight loss [14%], restlessness [12%], anxiety [10%], diarrhea and nausea [9%]; no mention of ALT elevations). 24255799
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to tetrabenazine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, none were attributed to tetrabenazine). 25754159
Huntington Study Group. Effect of deutetrabenazine on chorea among patients with Huntington disease: a randomized clinical trial. JAMA 2016; 316: 40-50. (Among 90 adults with Huntington disease and chorea treated with deutetrabenazine [tetrabenazine with deuterium which decreases CYP 2D6 activity and prolongs its half-life] or placebo for 12 weeks, chorea was improved with the active drug and changes in scores for side effects [depression, somnolence] and laboratory values were similar in the two groups). 27380342
Geschwind MD, Paras N. Deutetrabenazine for treatment of chorea in Huntington Disease. JAMA 2016; 316: 33-5. (Editorial in response to Huntington Study Group trial [2016] mentions that the degree of improvement in chorea was similar to that previously reported for tetrabenazine, but deutetrabenazine appeared to have fewer side effects). 27380339
Kim ES. Valbenazine: first global approval. Drugs 2017; 77: 1123-9. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of valbenazine shortly after its approval for use in tardive dyskinesia). 28578484
Valbenazine (Ingrezza) for tardive dyskinesia. Med Lett Drugs Ther 2017; 59 (1521): 83-4. (Concise review of the mechanism of action, clinical efficacy, safety and costs of valbenazine shortly after its approval for tardive dyskinesia in the US discusses common side effects and drug-drug interactions, but does not mention ALT elevations or hepatotoxicity). 28520698
Hauser RA, Factor SA, Marder SR, Knesevich MA, Ramirez PM, Jimenez R, Burke J et al. KINECT 3: a phase 3 randomized, double-blind, placebo-controlled trial of valbenazine for tardive dyskinesia. Am J Psychiatry 2017; 174: 476-84. (Among 234 adults with tardive dyskinesia treated with valbenazine [40 or 80 mg] or placebo daily for 6 weeks, abnormal involuntary movement scores improved with valbenazine but not placebo and adverse event rates were similar although among valbenazine treated subjects, one died suddenly, one had a suicide attempt and one had “reactivation of viral hepatitis”, although the authors state that there were “no clinically relevant changes from baseline” in key laboratory parameters). 28320223
Davis MC, Miller BJ, Kalsi JK, Birkner T, Mathis MV. Efficient trial design - FDA approval of valbenazine for tardive dyskinesia. N Engl J Med 2017; 376: 2503-6. (Commentary by FDA on design and facilitation of studies that led to rapid approval of valbenazine for tardive dyskinesia). 28489481
Factor SA, Remington G, Comella CL, Correll CU, Burke J, Jimenez R, Liang GS, et al. The effects of valbenazine in participants with tardive dyskinesia: results of the 1-year KINECT 3 Extension Study. J Clin Psychiatry 2017; 78: 1344-50. (In a 42 week extension study of valbenazine for tardive dyskinesia, 198 patients were treated for up to 48 weeks of whom 63% developed an adverse event which was serious in 15%, led to discontinuation in 16% [somnolence and suicidal ideation], and death in one [due to cardiac and hepatic failure which was assessed as not related to valbenazine]). 29141124
Fernandez HH, Factor SA, Hauser RA, Jimenez-Shahed J, Ondo WG, Jarskog LF, Meltzer HY, et al. Randomized controlled trial of deutetrabenazine for tardive dyskinesia: The ARM-TD study. Neurology 2017; 88: 2003-10. (Among 117 patients with tardive dyskinesia treated with tetrabenazine or placebo, abnormal involuntary movement scores improved more with tetrabenazine, but overall treatment success was similar as were total [48% vs 36%] and serious adverse event [5% vs 8%] rates; no mention of ALT elevations or hepatotoxicity). 28446646
Heo YA, Scott LJ. Deutetrabenazine: a review in chorea associated with Huntington's disease. Drugs 2017; 77: 1857-64. (Review of the pharmacology, clinical efficacy and safety of deutetrabenazine mentions that adverse event rates more frequent with deutetrabenazine than placebo were somnolence [11% vs 4%], dry mouth [9% vs 7%], diarrhea [9% vs 0%], insomnia [7% vs 4% and fatigue [7% vs 4%]; no mention of ALT elevations or hepatotoxicity). 29080203
Anderson KE, Stamler D, Davis MD, Factor SA, Hauser RA, Isojärvi J, Jarskog LF, et al. Deutetrabenazine for treatment of involuntary movements in patients with tardive dyskinesia (AIM-TD): a double-blind, randomised, placebo-controlled, phase 3 trial. Lancet Psychiatry 2017; 4: 595-604. (Among 298 patients with tardive dyskinesia treated with deutetrabenazine [12, 24 or 36 mg] or placebo daily, symptom improvements were more frequent with the two higher doses while both total and severe adverse event rates were similar in all groups; no mention of ALT elevations or hepatotoxicity). 28668671
Frank S, Stamler D, Kayson E, Claassen DO, Colcher A, Davis C, Duker A, et al.; Huntington Study Group/Alternatives for Reducing Chorea in Huntington Disease Investigators. Safety of converting from tetrabenazine to deutetrabenazine for the treatment of chorea. JAMA Neurol 2017; 74: 977-82. (Among 37 patients with Huntington disease who were switched from tetrabenazine to deutetrabenazine at a similar dose, there was no worsening of chorea, no withdrawal because of adverse events, and “no clinically significant differences in laboratory values”). 28692723
Niemann N, Jankovic J. Treatment of tardive dyskinesia: a general overview with focus on the vesicular monoamine transporter 2 inhibitors. Drugs 2018; 78: 525-41. (Review of the definition, clinical features, pathogenesis, epidemiology and management of tardive dyskinesia focusing upon the role, clinical efficacy and safety of VMAT2 inhibitors; no mention of ALT elevations or hepatotoxicity). 29484607
Scorr LM, Factor SA. VMAT2 inhibitors for the treatment of tardive dyskinesia. J Neurol Sci 2018; 389: 43-7. (Review of VMAT2 inhibitors and their efficacy and safety as therapy of tardive dyskinesia concludes that they are effective and safe). 29433808
Deutetrabenazine (Austedo) for Huntington's chorea and tardive dyskinesia. Med Lett Drugs Ther 2018; 60 (1545): 65-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of deutetrabenazine shortly after its approval in the US as therapy of Huntington disease and tardive dyskinesia mentions common side effects and drug-drug interactions as well as effects on QTc intervals, but does not mention ALT elevations or hepatotoxicity). 29667946

## OTHER REFERENCE LINKS

1. Recent References on Deutetrabenazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Deutetrabenazine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Deutetrabenazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Deutetrabenazine)
3. Recent References on Tetrabenazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tetrabenazine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
4. Trials on Tetrabenazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tetrabenazine)
5. Recent References on Valbenazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Valbenazine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
6. Trials on Valbenazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Valbenazine)